# Rimegepant

## OVERVIEW

### Introduction

Rimegepant is an orally available, small molecule inhibitor of the calcitonin gene-related peptide (CGRP) receptor that blocks the action of CGRP, a potent vasodilator believed to play a role in migraine headaches. Rimegepant is approved for both treatment and prevention of acute migraine attacks. In clinical trials, rimegepant was generally well tolerated with only rare instances of transient serum aminotransferase elevations during therapy and with no reported instances of clinically apparent liver injury.

### Background

Rimegepant (ri me’ je pant) is an orally available, small molecule inhibitor of the receptor for the calcitonin gene-related peptide (CGRP), which is believed to play a role in the pathogenesis of migraine headaches. CGRP is a potent vasodilator and pain-signaling neurotransmitter that is found throughout the central and peripheral nervous system but is particularly common in trigeminal ganglia. Levels of CGRP are elevated during episodes of migraine headache, and administration of the peptide can induce migraines in susceptible patients. For this reason, approaches to inhibition of CGRP signaling were developed as potential therapies for migraine, both as preventive therapies to decrease the rate of migraine as well as for treatment of acute attacks. Several small molecule inhibitors of the CGRP receptor (the “gepants”: atogepant, rimegepant, ubrogepant, and zavegepant) are available for treatment or prevention of acute migraine. Only rimegepant is approved for both indications. In several randomized, placebo controlled trials, rimegepant in doses of 75 mg orally (or sublingually) was found to increase the rate of being free of headache pain by two hours after administration [20% to 21% vs 11% to 12% with placebo] and also being free of the most bothersome other symptoms [35% to 38% vs 25% to 27% with placebo]. Rimegepant was approved for treatment of acute migraine in the United States in 2020, the second oral CGRP receptor antagonist approved for this indication. Indications were expanded in 2021 to also include prevention of acute attacks in patients with episodic migraine. Rimegepant is available in orally disintegrating tablets of 75 mg under the brand name Nurtec ODT. The recommended dose is 75 mg orally as soon as possible after onset of migraine. The dose should not exceed 75 mg during any 24-hour period. Rimegepant can be used by patients receiving preventive therapy with monoclonal antibodies to CGRP or its receptor. The recommended dose for prevention of migraines is 75 mg every other day. Rimegepant is generally well tolerated with side effects of nausea, dizziness, somnolence, and dry mouth that are generally uncommon (<5%), transient and mild-to-moderate in severity. Hypersensitivity reactions (largely rash and dyspnea) have arisen in rare cases, but more severe adverse events have not been reported.

### Hepatotoxicity

In preregistration controlled trials of rimegepant in several thousand patients, mild-to-moderate serum aminotransferase elevations arose in a small percentage of patients (1% to 2%) and overall rates were not different from those in placebo recipients. In the controlled trials and subsequently with general use, there have been no reports of clinically apparent liver injury attributed to rimegepant. In contrast, telcagepant, the initial oral CGRP receptor antagonist evaluated as therapy for migraine headaches, was abandoned during development because of several instances of clinically apparent liver injury in recipients that was characterized by marked elevations in serum aminotransferase levels and symptoms of fatigue, nausea and abdominal discomfort arising within 2 to 4 weeks of starting therapy which rapidly resolved with stopping therapy. Similar episodes have not been reported with rimegepant.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to rimegepant are not known. It is metabolized in the liver largely by CYP 3A4 and is susceptible to drug-drug interactions with agents that induced or inhibit this microsomal enzyme.

### Outcome and Management

Drug Class: Migraine Headache Agents

Other Small Molecule Inhibitors of CGRP Receptors: [underlined: Atogepant], Ubrogepant, Zavegepant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rimegepant – Nurtec ODT®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rimegepant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Rimegepant | 1289023-67-1 | C28-H28-F2-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 12 January 2025

Abbreviations: CGRP, calcitonin gene-related peptide.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of CGRP antagonists).
FDA. Clinical Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212728Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the rimegepant application including specific discussion of hepatic adverse events which consisted mainly of mild-to-moderate ALT or AST elevations which were similar in frequency in rimegepant vs placebo recipients and there were no instances of clinically apparent liver injury with jaundice).
Ho TW, Connor KM, Zhang Y, Pearlman E, Koppenhaver J, Fan X, Lines C, et al. Randomized controlled trial of the CGRP receptor antagonist telcagepant for migraine prevention. Neurology 2014; 83: 958-66. (Among 660 patients with migraine enrolled in a controlled trial of telcagepant [140 or 280 mg] vs placebo twice daily for 12 weeks, 13 patients on telcagepant developed ALT elevations above 3 times ULN, generally between weeks 4 and 6 of treatment, two rising starting at week 2 to as high as 33 and 39 times ULN accompanied by symptoms but not jaundice; discontinuation was followed by full recovery but the episodes led to early termination of the trial because of the risk of significant hepatotoxicity). 25107879
Marcus R, Goadsby PJ, Dodick D, Stock D, Manos G, Fischer TZ. BMS-927711 for the acute treatment of migraine: a double-blind, randomized, placebo controlled, dose-ranging trial. Cephalalgia 2014; 34(2): 114-25. (Among 885 adults enrolled in a randomized controlled dose-finding study of rimegepant [10, 25, 75, 150, 300 or 600 mg] for treatment of a single migraine attack, the proportion of subjects who were headache pain free 2 hours after dosing was 30-33% with 75, 150 and 300 mg of rimegepant vs 35% with sumatriptan and 15% with placebo, while adverse event rates were similar in all groups and there were no “clinically significant changes” in laboratory tests and no ALT elevations above 3 times ULN). 23965396
Lipton RB, Croop R, Stock EG, Stock DA, Morris BA, Frost M, Dubowchik GM, et al. Rimegepant, an oral calcitonin gene-related peptide receptor antagonist, for migraine. N Engl J Med 2019; 381: 142-9. (Among 1186 adults treated for a single migraine attack in a randomized controlled trial, freedom from headache pain at 2 hours was higher with rimegepant [75 mg] than placebo [20% vs 12%] as was resolution of the most bothersome other symptom [38% vs 25%] while adverse event rates were similar, ALT or AST elevations arising in 2.4% vs 2.0% and no elevation being above 3 times ULN). 31291516
Croop R, Goadsby PJ, Stock DA, Conway CM, Forshaw M, Stock EG, Coric V, et al. Efficacy, safety, and tolerability of rimegepant orally disintegrating tablet for the acute treatment of migraine: a randomised, phase 3, double-blind, placebo-controlled trial. Lancet 2019; 394: 737-45. (Among 1811 adults treated for a single attack of migraine in a randomized controlled trial, freedom from headache pain 2 hours after dosing was higher after rimegepant [75 mg] vs placebo [21% vs 11%] as was freedom from the most bothersome other symptom [35% vs 27%], while the most common adverse event was nausea [2% vs 1%] and ALT elevations above 3 times ULN occurred in 0.1% of both groups and there were no instances of liver injury with jaundice). 31311674
Tfelt-Hansen P, Loder E. The Emperor's new gepants: are the effects of the new oral CGRP antagonists clinically meaningful? Headache 2019; 59: 113-7. (Commentary on the relative efficacy of two oral CGRP receptor antagonists, ubrogepant and rimegepant, which show only modest efficacy in acute migraine [therapeutic gain of 5-8%] and only when compared to placebo as compared to well known effective therapies such as aspirin and other nonsteroidal antiinflammatory agents [8-14%] and the triptans [16-32%]). 30451300
Lasmiditan (Reyvow) and ubrogepant (Ubrelvy) for acute treatment of migraine. Med Lett Drugs Ther 2020; 62: 35-9. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ubrogepant and lasmiditan as therapy of acute migraine shortly after their approval for this indication in the US, mentions side effects of ubrogepant being nausea and somnolence but does not mention ALT elevations or hepatotoxicity). 32555120
Rimegepant (Nurtec ODT) for acute treatment of migraine. Med Lett Drugs Ther 2020; 62: 70-2. (Concise review of the mechanism of action, pharmacology, clinical efficacy, safety and cost of rimegepant shortly after its approval in the US as therapy of acute migraine in adults, mentions that it “was generally well tolerated in clinical trials; nausea was the most common adverse event [~2%]”). 32555113
Berman G, Croop R, Kudrow D, Halverson P, Lovegren M, Thiry AC, Conway CM, et al. Safety of rimegepant, an oral CGRP receptor antagonist, plus CGRP monoclonal antibodies for migraine. Headache 2020; 60: 1734-42. (Description of 13 patients taking CGRP monoclonal antibodies for prevention of migraine [erenumab, galcanezumab or fremanezumab] who used rimegepant tablets to treat a total of 224 acute attacks of migraine, with no serious adverse events and no elevations in ALT above 3 times ULN or episodes of liver injury with jaundice). 32799325
Croop R, Lipton RB, Kudrow D, Stock DA, Kamen L, Conway CM, Stock EG, et al. Oral rimegepant for preventive treatment of migraine: a phase 2/3, randomised, double-blind, placebo-controlled trial. Lancet 2021; 397: 51-60. (Among 747 patients with migraine headaches enrolled in a 12 week randomized controlled trial, those treated with rimegepant [75 mg] every other day had a greater decrease in monthly number of days with migraine vs those on placebo [-4.3 vs -3.5 days], while overall adverse event rates were similar [both 36%] as were ALT or AST elevations above 3 times ULN [both 1%], and there were no instances of liver injury with jaundice, although 1 patient receiving rimegepant had an asymptomatic and transient elevation in ALT above 10 times ULN). 33338437
Drugs for migraine. Med Lett Drugs Ther 2020; 62: 153-60. (Concise summary of the relative clinical efficacy, safety and costs of drugs to treat acute migraine headache [such as analgesics, opiates, triptans, ergots and oral CGRP receptor antagonists] and to prevent migraines [such as anticonvulsants, beta blockers, antidepressants and the monoclonal antibodies to CGRP and its receptor]). 33434187
Robbins MS. Diagnosis and management of headache: a review. JAMA 2021; 325: 1874-85. (Review of the diagnosis and management of headache including use of calcitonin gene-related peptide antagonists for acute migraine attacks which has uncommon side effects of dry mouth and dizziness; no mention of ALT elevations or hepatotoxicity). 33974014
Woodhead JL, Siler SQ, Howell BA, Watkins PB, Conway C. Comparing the liver safety profiles of 4 next-generation CGRP receptor antagonists to the hepatotoxic CGRP inhibitor telcagepant using quantitative systems toxicology modeling. Toxicol Sci. 2022;188:108-116. (Mechanistic simulation of hepatotoxicity indicated that telcagepant had multiple potential adverse effects on liver function compared to the more recently developed CGRP antagonists, rimegepant, ubrogepant, atogepant, and zavegepant). 35556143
Battini V, Carnovale C, Clementi E, Sessa M. Ubrogepant and rimegepant: signal detection using spontaneous reports of adverse events from the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023;22:1105-1112. (Extraction of adverse event reports made to the FDAs Adverse Event Reporting System for ubrogepant [n=2010] and rimegepant [3691] found no excess reports of hepatic reactions). 37293948
Croop R, Lipton RB, Kudrow D, Stock DA, Kamen L, Conway CM, Stock EG, et al. Oral rimegepant for preventive treatment of migraine: a phase 2/3, randomised, double-blind, placebo-controlled trial. Lancet. 2021;397(10268):51-60. (Among 695 adults with episodic or chronic migraine treated with rimegepant [75 mg] or placebo every other day for 12 weeks, the mean number of migraine days per month decreased more with drug [-4.3] than placebo [-3.5], while total and serious adverse event rates were similar [36% vs 36% and 1% vs 1%] as were rates of serum ALT or AST elevations above 3 times ULN [1% vs 1%], and there were no instances of ALT elevations with jaundice or symptoms). 33338437
Drugs for migraine. Med Lett Drugs Ther. 2023;65:89-96. (Concise summary of the relative clinical efficacy, safety, and costs of drugs to treat and to prevent migraine headaches, states that systemic adverse effects are uncommon with use of oral CGRP receptor antagonists, but that nausea and somnolence can occur; no mention of ALT elevations or hepatotoxicity). 37266987
Liang Q, Liao X, Wu H, Huang Y, Liang T, Li H. Real-world study of adverse events associated with gepant use in migraine treatment based on the VigiAccess and U.S. Food and Drug Administration's adverse event reporting system databases. Front Pharmacol. 2024;15:1431562. (Search of two large registry databases on spontaneous reports of adverse events due to -gepants [rimegepant, ubrogepant, and atogepant] identified 23,542 reports, but only 0.09% to 0.27% were liver related, attesting to the lack of severe liver injury due to the currently available oral CGRP receptor antagonists). 39144633
Croop R, Berman G, Kudrow D, Mullin K, Thiry A, Lovegren M, L'Italien G, et al. A multicenter, open-label long-term safety study of rimegepant for the acute treatment of migraine. Cephalalgia. 2024;44:3331024241232944. (Among 1600 adults with episodic or chronic migraine treated with rimegepant [75 mg] in 3 different dose regimens either as needed for an acute attacks or as preventive therapy with addition of doses as needed, ALT or AST elevations arose in 11% of patients and were above 3 times ULN in only 1%, none of whom that were considered possibly due to drug were associated with bilirubin elevations or clinically apparent liver injury). 38659334
Lipton RB, Thiry A, Morris BA, Croop R. Efficacy and safety of rimegepant 75 mg oral tablet, a CGRP receptor antagonist, for the acute treatment of migraine: a randomized, double-blind, placebo-controlled trial. J Pain Res. 2024;17:2431-2441. (Among 1162 adults with migraine headaches who were treated during an acute attack with rimegepant [75 mg] or placebo, 2 hour post dosing pain free rates were 19% vs 14%, while adverse event rates were 12.6% vs 10.7%, and ALT or AST elevations arose in only 2% vs 3.6% of participations, and were above 3 times ULN in only 1 patient in each group, none developing jaundice or symptoms). 39070853
Hu JL, Wu JY, Xu S, Qian SY, Jiang C, Zheng GQ. Post-marketing safety concerns with rimegepant based on a pharmacovigilance study. J Headache Pain. 2024;25:169. (Among 5.4 million drug adverse event reports received by the FDA’s Adverse Event Reporting System between 2020 and 2023, 10,194 were associated with rimegepant use and involved 27 different organ systems; hepatobiliary reactions were not mentioned). 39375581
Pan H, Lin S. A real-world adverse events study of rimegepant from the FAERS database. Expert Opin Drug Saf. 2024:1-6. Epub ahead of print. (Among 6659 spontaneous adverse event reports submitted to the FDA’s Adverse Event Reporting System that were associated with rimegepant use, only 15 were categorized as hepatobiliary; no details provided). 39412590

## OTHER REFERENCE LINKS

1. Recent References on Rimegepant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rimegepant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Rimegepant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rimegepant)